# Pasireotide

## OVERVIEW

### Introduction

Pasireotide is a synthetic polypeptide analogue of somatostatin that resembles the native hormone in its ability to suppress levels and activity of growth hormone, insulin, glucagon and many other gastrointestinal peptides. Because its half-life is longer than somatostatin, pasireotide can be used clinically to treat neuroendocrine pituitary tumors that secrete excessive amounts of growth hormone causing acromegaly, or adrenocorticotropic hormone (ACTH) causing Cushing disease. Pasireotide has many side effects including suppression of gall bladder contractility and bile production, and maintenance therapy can cause cholelithiasis and accompanying elevations in serum enzymes and bilirubin.

### Background

Pasireotide (pa" ze ree' oh tide) is a synthetic octapeptide and analogue of somatostatin that is used for its ability to suppress levels and activities of hormones (growth hormone, insulin, gastrin, secretin, glucagon) or active neuropeptides (serotonin, vasoactive intestinal polypeptide [VIP]). Natural somatostatin is produced in the hypothalamus and acts to suppress growth hormone release from the pituitary. Somatostatin is also found in other neurons throughout the body and particularly in intestinal and pancreatic neurons, where it is active in suppressing release of hormones and neuropeptides such as insulin, glucagon, ACTH, gastrin, secretin, motilin, VIP, serotonin and cholecystokinin. Because of its short half-life (~3 minutes), somatostatin is impractical as a therapeutic agent, and analogues have been developed that have a more favorable pharmacological profile such as octreotide, pasireotide and lanreotide, all three of which have been marketed in long acting release (LAR) forms to allow once weekly or monthly administration. Pasireotide appears to interact largely with the somatostatin subtypes 1, 2 and 3 and possibly subtype 5 receptors, but otherwise acts in a similar manner to somatostatin. Pasireotide therapy has been shown to improve symptoms and complications of several neuroendocrine tumors including abnormal growth in acromegaly due to growth hormone secreting pituitary tumors and symptoms of excessive glucocorticoid production due to ACTH secreting pituitary tumors. Pasireotide was approved for use in treating Cushing disease in the United States in 2012 and a long acting form for as treatment of acromegaly in 2014. Pasireotide is available under the brand name Signifor in single dose ampules of 0.3, 0.6 and 0.8 mg in one mL solution for injection which is administered as a subcutaneous injection in doses of 0.3 to 0.9 mg twice daily (for Cushing disease). Pasireotide has been formulated also in a long acting release form under the brand name Signifor LAR, in 20, 40 and 60 mg vials of powder for reconstitution, the recommended dose (acromegaly) being 40 mg by intramuscular injection every 4 weeks with subsequent titration based upon efficacy and tolerance. Side effects are common. Adverse events from single injections include influenza-like symptoms of fatigue, headache, nausea and vomiting and local infusion reactions. With continued therapy, adverse events can include diarrhea, abdominal pain, back pain, headache, dizziness, hypothyroidism, hypo- and hyperglycemia, arrhythmias and gall bladder disease.

### Hepatotoxicity

Mild, transient, asymptomatic elevations in serum aminotransferase levels occur in up to 29% of patients receiving pasireotide LAR, but elevations above 5 times the upper limit of normal are rare (<1%) and no case of clinically apparent liver injury with jaundice was reported in the preregistration trials of pasireotide in acromegaly. In some instances, the serum enzyme elevations appeared to reflect cholelithiasis and cholecystitis rather than hepatic injury and in all cases the abnormalities resolved, usually without dose modification or discontinuation. Similar or greater rates of liver test abnormalities were observed with octreotide LAR therapy. Since its approval and more widescale use, there have been no published reports of liver injury or hepatitis attributed to pasireotide. The product label for pasireotide mentions that hepatic serum enzyme elevations can occur on therapy and recommends monitoring “prior to and during therapy.”

Pasireotide causes inhibition of gall bladder contractility and a decrease in bile secretion, and long term therapy is associated with a high rate of cholesterol gallstone formation. In prospective studies, between 20% and 30% of patients with acromegaly treated with maintenance pasireotide for one to two years developed gallstones detected by ultrasonography and a proportion developed symptomatic cholelithiasis requiring hospitalization and cholecystectomy. Even after cholecystectomy, cholesterol stones may form in the common bile duct and intrahepatic ducts during somatostatin analogue therapy which can cause symptoms and liver test abnormalities. Therapy with ursodiol does not appear to prevent gallstone formation related to somatostatin analogue therapy, although it may help.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent hepatobiliary injury).

### Mechanism of Injury

Pasireotide, like somatostatin, decreases cholecystokinin secretion, gall bladder contractility and bile secretion, perhaps accounting for the high rate of gall bladder sludge and stone formation with long term use. How infusions of pasireotide might cause acute liver injury independent of its effect on bile flow and gall bladder function is uncertain. Pasireotide is a polypeptide and, as such, should not have direct or even indirect hepatic toxicity. Thus, the liver injury, like the gall bladder effects, is likely caused by what pasireotide does, rather than by its chemical structure or what it is. Pasireotide has multiple effects on the gastrointestinal tract, including effects on gastrointestinal hormone levels, motility, transit time, bacterial flora, and bile acid concentrations.

### Outcome and Management

The product label for pasireotide recommends evaluation of “liver enzyme test prior to and during treatment.” The liver test abnormalities during pasireotide therapy generally resolve rapidly with stopping therapy, but may resolve even with drug continuation. Patients should be monitored if pasireotide is restarted after liver test abnormalities resolve. Nevertheless, in many instances, pasireotide has been restarted without recurrence. There is little information on cross sensitivity to liver injury among the different somatostatin analogues, but liver injury has been reported most frequently with octreotide.

Drug Class: Hormonal Agents; Antineoplastic Agents; Gastrointestinal Agents

Other Drugs in the Subclass, Hormonal Agents, Somatostatin Analogues: Lanreotide, Octreotide

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pasireotide – Signifor®, Signifor LAR®

DRUG CLASS

Hormonal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Pasireotide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Lanreotide | 108736-35-2 | C54-H69-N11-O10-S2
Octreotide | 83150-76-9 | C49-H66-N10-O10-S2 | Octreotide structure
Pasireotide | 396091-73-9 | C58-H66-N10-O9
Somatostatin | 51110-01-1 | Protein | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 20 April 2017

Zimmerman HJ. Hepatic injury from the treatment of infectious and parasitic diseases. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 589-637. (Expert review of hepatotoxicity published in 1999 and before the availability of pasireotide or lanreotide).
Kaplowitz N, DeLeve LD, eds. Drug-induced Liver Disease. 3rd edition. Amsterdam: Elsevier, 2013. (Multiauthored text book on drug induced liver injury; does not discuss lanreotide or pasireotide).
Sharkey KA, Wallace JL. Treatment of disorders of bowel motility and water flux: anti-emetics; agents used in biliary and pancreatic disease. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1323-49. (Textbook of pharmacology and therapeutics).
Petersenn S, Schopohl J, Barkan A, Mohideen P, Colao A, Abs R, Buchelt A, et al.; Pasireotide Acromegaly Study Group. Pasireotide (SOM230) demonstrates efficacy and safety in patients with acromegaly: a randomized, multicenter, phase II trial. J Clin Endocrinol Metab 2010; 95: 2781-9. (Among 60 patients with acromegaly treated with 28 days of octreotide [three times daily] crossed over to pasireotide [200, 400 or 600 µcg twice daily], biochemical responses were more frequent with pasireotide and common adverse events were nausea [25%], diarrhea [22%], abdominal pain [12%] and diabetes [5%]; no mention of ALT elevations or serious liver related adverse events). 20410233
Pasireotide (Signifor) for Cushing’s Disease. Med Lett Drugs Ther 2013; 55 (1416): 39-40. (Concise review of the mechanism of action, clinical efficacy, safety and costs of pasireotide shortly after its approval for use in Cushing disease in the US; mentions adverse reactions of diarrhea, nausea, cholelithiasis, abdominal pain, headache and fatigue and that hyperglycemia, hypercortisolism, QT prolongation, pituitary hormone deficiencies and hepatic enzyme elevations can also occur). 23669783
Colao A, Bronstein MD, Freda P, Gu F, Shen CC, Gadelha M, Fleseriu M, et al.; Pasireotide C2305 Study Group. Pasireotide versus octreotide in acromegaly: a head-to-head superiority study. J Clin Endocrinol Metab 2014; 99: 791-9. (Among 358 patients with acromegaly and no previous medical therapy treated with monthly injections of either pasireotide or octreotide for 12 months, biochemical control of growth hormone and insulin-like growth factor levels were more frequent with pasireotide than octreotide as was hyperglycemia [29% vs 8%], while cholelithiasis arose commonly in both groups [26% vs 36%]; no mention of ALT elevations or hepatotoxicity). 24423324
Gadelha MR, Bronstein MD, Brue T, Coculescu M, Fleseriu M, Guitelman M, Pronin V, et al.; Pasireotide C2402 Study Group. Pasireotide versus continued treatment with octreotide or lanreotide in patients with inadequately controlled acromegaly (PAOLA): a randomised, phase 3 trial. Lancet Diabetes Endocrinol 2014; 2: 875-84. (Among 198 patients with acromegaly inadequately controlled on octreotide or lanreotide crossed over to pasireotide or continued on previous regimen for 24 weeks, 15-20% of the pasireotide treated versus none continued on the previous regimen achieved biochemical control of the acromegaly, while adverse events included hyperglycemia in 31-33% of pasireotide vs 9% of active control subjects, cholelithiasis in 10% vs 12% and one subject on pasireotide required dose interruption because of abnormal liver test results [no details provided]). 25260838
Sheppard M, Bronstein MD, Freda P, Serri O, De Marinis L, Naves L, Rozhinskaya L, et al. Pasireotide LAR maintains inhibition of GH and IGF-1 in patients with acromegaly for up to 25 months: results from the blinded extension phase of a randomized, double-blind, multicenter, Phase III study. Pituitary 2015; 18: 385-94. (Among patients with acromegaly who had a beneficial response to somatostatin analogue therapy in a prospective trial [Colao 1914] and were continued on therapy for 26 months, clinical responses were mostly maintained and no new adverse reactions were identified, 31% of pasireotide treated subjects developed hyperglycemia and 30% cholelithiasis; no mention of ALT elevations or hepatotoxicity). 25103549
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one case was attributed to octreotide, but none to lanreotide or pasireotide). 25754159
McKeage K. Pasireotide in acromegaly: a review. Drugs 2015; 75: 1039-48. (Review of the mechanism of action, pharmacology, clinical efficacy and safety of pasireotide as therapy of acromegaly; does not mention ALT elevations or hepatotoxicity). 26017304
Bronstein MD, Fleseriu M, Neggers S, Colao A, Sheppard M, Gu F, Shen CC, et al.; Pasireotide C2305 Study Group. Switching patients with acromegaly from octreotide to pasireotide improves biochemical control: crossover extension to a randomized, double-blind, Phase III study. BMC Endocr Disord 2016; 16: 16. (Among the 358 patients with acromegaly enrolled in a controlled trial comparing pasireotide to octreotide for 12 months [Colao 2014], 119 did not achieve biochemical control and were crossed over to the other regimen for 12 months, and 17% of 81 switched to pasireotide vs none of 38 switched to octreotide had a biochemical response; while adverse event rates were similar, but hyperglycemia was more frequent with pasireotide [32% vs 13%] while cholelithiasis rates were similar [20% vs 19%]; no mention of ALT elevations or hepatoxicity). 27039081
Öberg K, Lamberts SW. Somatostatin analogues in acromegaly and gastroenteropancreatic neuroendocrine tumours: past, present and future. Endocr Relat Cancer 2016; 23: R551-R566. (Review of the use of somatostatin analogues such as oct-, pasi- and lan-reotide for acromegaly and neuroendocrine tumors; mentions that one-third to one-half of patients on somatostatin analogues can develop gallstones or biliary sludge). 27697899
Fleseriu M, Rusch E, Geer EB; ACCESS Study Investigators. Safety and tolerability of pasireotide long-acting release in acromegaly-results from the acromegaly, open-label, multicenter, safety monitoring program for treating patients who have a need to receive medical therapy (ACCESS) study. Endocrine 2017; 55: 247-255. (Among 44 patients with acromegaly treated with pasireotide [40 mg every 28 days] for 4-70 weeks, hyperglycemia requiring antidiabetic therapy developed in 48% and there were 8 episodes of cholelithiasis, but there were apparently no liver related adverse events). 27896545

## OTHER REFERENCE LINKS

1. Recent References on Pasireotide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Pasireotide+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Pasireotide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pasireotide)